# Clopidogrel

## OVERVIEW

### Introduction

Clopidogrel is an inhibitor of platelet aggregation that is used to decrease the risk of myocardial infarction and stroke in patients known to have atherosclerosis. Clopidogrel has been linked to rare instances of idiosyncratic, clinically apparent acute liver injury.

### Background

Clopidogrel (kloe pid' oh grel) is an inhibitor of adenosine diphosphate (ADP)-induced platelet aggregation and is used widely to decrease the risk of myocardial infarction and stoke in patients who have documented coronary or cerebrovascular disease or previous heart attack or stroke. Activated platelets release ADP which binds to platelet receptors, causing activation of intracellular glycoprotein IIb/IIIA complex which triggers platelet adherence and aggregation. The aggregation of platelets plays an important role in the growth of atheromatous plaques, which can lead to coronary, cerebral and peripheral arterial occlusions. In large clinical trials, clopidogrel therapy has been shown to decrease the frequency of recurrence of myocardial infarction and stroke. Clopidogrel was approved for use in the United States in 1997 and is widely used, with more than 1.5 million prescriptions filled yearly. Current indications include reduction of atherosclerotic events (myocardial infarction, stroke, vascular death) in patients with documented atherosclerosis and in patients with acute myocardial infarction or unstable angina. Clopidogrel is available in 75 mg tablets generically and under the brand name of Plavix. The usual dose is 75 mg daily, sometimes with a loading dose of 300 mg on day one. Side effects are not common, but can include headache, dizziness, fatigue, gastrointestinal upset, nausea, arthralgias and rash.

### Hepatotoxicity

Clopidogrel is associated with serum enzyme elevations in 1% to 3% of patients during therapy. In several large clinical trials, elevations of serum ALT were no more frequent with clopidogrel as with placebo (or in comparator arms) and no instances of clinically apparent liver injury were reported. Since marketing and release, however, there have been more than a dozen published case reports of clinically apparent liver injury attributed to clopidogrel. The onset of symptoms was within 2 to 24 weeks (averaging 6 weeks) of starting, with fatigue and jaundice. Several patients had an accompanying fever but rash and eosinophilia were not common. The usual pattern of liver enzyme elevations was hepatocellular, but cases with mixed or cholestatic enzyme elevations have also been described (Case 1). Autoantibodies were rarely present. Most cases were self-limited with recovery within 1 to 2 months, but rare cases of acute liver failure or hepatic decompensation with death or need for liver transplantation have been described.

Likelihood score: B (highly likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of clopidogrel hepatotoxicity is not known, but is clearly idiosyncratic and may be due to the complex hepatic metabolism of the clopidogrel molecule. Immunoallergic features are usually not prominent, but hypersensitivity reactions to clopidogrel have been described. The effectiveness of clopidogrel is dependent upon its activation in the liver by CYP 2C19 and poor metabolizers of this enzyme may not respond adequately to its antiplatelet activity. Furthermore, it is susceptible to drug-drug interactions with agents that induce or inhibit CYP 2C19.

### Outcome and Management

The severity of liver injury associated with clopidogrel ranges from transient, mild serum enzyme elevations to clinically apparent acute hepatitis that can be severe and lead to death. Most cases resolve with drug withdrawal within 1 to 3 months. Rechallenge with clopidogrel usually results in recurrence of liver injury and should be avoided. However, there does not appear to be cross sensitivity to the liver injury between clopidogrel and ticlopidine or dipyridamole.

Drug Class: Antithrombotic Agents, Antiplatelet Agents

Other Drugs in the Subclass, Antiplatelet Agents: Aspirin, Cangrelor, Dipyridamole, Prasugrel, Ticagrelor, Ticlopidine, Vorapaxar

## CASE REPORT

### Case 1. Acute cholestatic hepatitis due to clopidogrel.

[Modified from: Chau TN, Yim KF, Mok NS, Chan WK, Leung VK, Leung MF, Lai ST. Clopidogrel-induced hepatotoxicity after percutaneous coronary stenting. Hong Kong Med J 2005; 11: 414-6. [PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16219965)]

A 74 year old man with a history of hypertension and ischemic heart disease presented with retrosternal chest pain and underwent cardiac catheterization which showed complete occlusion of the left anterior descending and 80% occlusion of the left circumflex artery for which he underwent successful percutaneous stenting. Clopidogrel was started in preparation of the coronary artery stenting and continued after discharge. Four weeks later and 41 days after starting clopidogrel he developed dark urine and jaundice. He had no previous history of liver disease, drug allergies, alcohol abuse, or risk factors for viral hepatitis. Other medications included aspirin, isosorbide dinitrate and metoprolol, all of which had been taken for several years. Laboratory testing showed a serum bilirubin of 5.3 mg/dL, ALT 212 U/L and alkaline phosphatase 172 U/L (Table). Serum albumin concentrations and prothrombin time were normal. Tests for acute hepatitis A, B, C (including HCV RNA) and E were negative as were smooth muscle and antinuclear antibodies. Abdominal ultrasound showed no hepatic masses or evidence of biliary obstruction. Four days after onset of jaundice, clopidogrel was stopped, while other medications were continued. Liver tests worsened for the first few days after presentation, but then began to improve and were within the normal range 3 months later.

#### Key Points

Medication: | Clopidogrel (75 mg daily for 41 days)
Pattern: | Mixed (R=3.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 41 days
Recovery: | 3 months
Other medications: | Aspirin, isosorbide dinitrate, metoprolol

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
1 day | | 30 | 65 | 0.5 | Clopidogrel started
1 week | | 25 | 75 | 0.5 | Cardiac catheterization
2 weeks | | 25 | 70 | 0.4
6 weeks | 0 | 212 | 172 | 5.3 | Clopidogrel stopped
| 2 days | 253 | 202 | 5.8
| 3 days | 205 | 185 | 3.6
7 weeks | 5 days | 140 | 155 | 2.0
10 weeks | 1 month | 86 | 110 | 0.4
17 weeks | 3 months | 25 | 90 | 0.4
Normal Values | | <40 | <115 | <1.2

* Some values estimated from figure.

#### Comment

A typical example of an acute liver injury with jaundice attributed to clopidogrel. Typical were the time of onset (4-5 weeks), the mixed pattern of serum enzyme elevations and the mild self-limited nature of the injury, with improvement starting within a week of stopping the medication. While the liver injury from clopidogrel resembles that of ticlopidine, there are some differences. Both agents are associated with acute liver injury that usually arises within 1 to 12 weeks of starting. However, the injury tends to be more hepatocellular with clopidogrel and the time to recovery slightly shorter. Interestingly, there does not seem to be cross sensitivity to hepatic injury between clopidogrel and ticlopidine, despite their similar chemical structures and mechanisms of action.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clopidogrel – Generic, Plavix®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Clopidogrel)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clopidogrel | 90055-48-4 | C16-H16-Cl-N-O2-S | Clopidogrel Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 October 2017

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999 discusses ticlopidine, but not clopidogrel).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 528. (Review of hepatotoxicity of antiplatelet drugs mentions that clopidogrel like ticlopidine can cause liver injury although less commonly, and some patients with ticlopidine liver injury can tolerate clopidogrel without recurrence).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
A randomised, blinded, trial of clopidogrel versus aspirin in patients at risk of ischaemic events (CAPRIE). CAPRIE Steering Committee. Lancet 1996; 348: 1329-39. (Among 19,185 patients treated with either aspirin or clopidogrel and followed for an average of 1.9 years, abnormal liver tests were reported in 3% on clopidogrel vs 3.2% on aspirin and were severe in 0.5% vs 0.7%). 8918275
Zeolla MM, Carson JJ. Successful use of clopidogrel for cerebrovascular accident in a patient with suspected ticlopidine-induced hepatotoxicity. Ann Pharmacoth 1999; 33: 939-41. (79 year old woman developed elevations in serum enzymes 5 weeks after starting ticlopidine [bilirubin 0.3 mg/dL, ALT 1008 U/L, Alk P 648 U/L] without jaundice or symptoms, and levels fell to near normal within 20 days of switching to clopidogrel and were completely normal 4 months later). 10492495
Jarvis B, Simpson K. Clopidogrel: a review of its use in the prevention of atherothrombosis. Drugs 2000; 60: 347-77. (Review of the mechanism of action, pharmacokinetics, efficacy and safety of clopidogrel; side effects are slightly less common with clopidogrel than aspirin, serum enzyme elevations occurring in 3% vs 3.2% [CAPRIE]). 10983738
Willens HJ. Clopidogrel-induced mixed hepatocellular and cholestatic liver injury. Am J Ther 2000; 7: 317-8. (81 year old woman developed fatigue and anorexia 2 weeks and jaundice 4 weeks after starting clopidogrel [bilirubin 3.0 mg/dL, ALT 507 U/L, Alk P 636 U/L], resolving within 2 months of stopping). 11317178
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, et al. Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology 2002; 36: 451-5. (Among 34 cases of drug induced liver injury identified in a population based survey in France [1997-2000], 1 case was attributed to clopidogrel, occurring in a 75 year old woman [bilirubin 6.6 mg/dL, ALT 8 times ULN, Alk P 2 times ULN], resolving within 1 month). 12143055
Durán Quintana JA, Jiménez Sáenz M, Montero AR, Gutiérrez MH. [Clopidogrel probably induced hepatic toxicity]. Med Clin (Barc) 2002; 119: 37. Spanish. (77 year old man developed jaundice 6 months after starting clopidogrel [bilirubin 13 mg/dL, ALT 786 U/L, Alk P 474 U/L], resolving within 4 months of stopping). 12062007
Ramos Ramos JC, Sanz Moreno J, Calvo Carrasco L, García Díaz Jde D. [Clopidogrel-induced hepatotoxicity]. Med Clin (Barc) 2003; 120: 156-7. Spanish. (89 year old woman developed jaundice 8 weeks after starting clopidogrel [bilirubin 24.9 rising to 33.8 mg/dL, ALT 720 U/L, Alk P 118 U/L], resolving within 5 months of stopping). 12605844
Wolf I, Mouallem M, Rath S, Farfel Z. Clopidogrel-induced systemic inflammatory response syndrome. Mayo Clin Proc 2003; 78: 618-20. (50 year old woman developed fever, weakness and rash 2 weeks after starting clopidogrel [bilirubin 1.3 mg/dL, ALT 149 U/L, Alk P 132 U/L], resolving rapidly upon stopping and with positive rechallenge [fever and tachycardia within 4 hours]). 12744550
Batwa F, Lamoureaux E, Friedman G. Clopidogrel-induced liver injury [case report]. Can J Gastroenterol 2003; 17: 232. Not in PubMed (Cited in Goyal et al. [2009], 84 year old woman developed mixed pattern of liver injury 56 days after starting clopidogrel, with resolution on follow up).
Beltran-Robles M, Marquez Saavedra E, Sanchez-MuñD, Romero-Gomez M. Hepatotoxicity induced by clopidogrel. J Hepatol 2004; 40: 560-2. (59 year old man developed abnormal liver tests 4 days after starting clopidogrel [bilirubin 0.5 mg/dL, ALT 318 U/L, Alk P 100 U/L], resolving in 11 days of stopping and recurring within 4 days of restarting [ALT 119]). 15123377
Chau TN, Yim KF, Mok NS, Chan WK, Leung VK, Leung MF, Lai ST. Clopidogrel-induced hepatotoxicity after percutaneous coronary stenting. Hong Kong Med J 2005; 11: 414-6. (74 year old man developed jaundice 5 weeks after starting clopidogrel [bilirubin 5.3 mg/dL, ALT 212 U/L, Alk P 172 U/L], resolving within 4 weeks of stopping: Case 1). 16219965
Ng JA, Goldberg N, Tafreshi MJ. Clopidogrel-induced hepatotoxicity and fever. Pharmacotherapy 2006; 26: 1023-6. (59 year old woman developed fever 3 days after starting clopidogrel [bilirubin 1.5 mg/dL, ALT 536 U/L, Alk P 247 U/L, eosinophils 10%], fevers and laboratory abnormalities resolving with stopping, and recurring on restarting clopidogrel but then able to tolerate ticlopidine). 16878371
Höllmüller I, Stadlmann S, Graziadei I, Vogel W. Clinico-histopathological characteristics of clopidogrel-induced hepatic injury: case report and review of literature. Eur J Gastroenterol Hepatol 2006; 18: 931-4. (80 year old man developed jaundice 6 weeks after starting clopidogrel [bilirubin 13.2 rising to 20.8 mg/dL, ALT 854 U/L, Alk P 221 U/L], resolving within 2 months of stopping). 16825915
López-Vicente J, Garfia C, López-Medrano F, Yela C. [Hepatic toxicity and clopidogrel-induced systemic inflammatory response syndrome]. Rev Esp Cardiol 2007; 60: 323-4. Spanish. (63 year old man developed fever and abdominal pain 4 weeks after starting clopidogrel [bilirubin 1.0 mg/dL, ALT 204, Alk P 682 U/L, eosinophils 3037/µL], resolving upon stopping clopidogrel). 17394881
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to ticlopidine or clopidogrel). 18955056
Wiper A, Schmitt M, Roberts DH. Clopidogrel-induced hepatotoxicity. J Postgrad Med 2008; 54: 152. (56 year old man developed fatigue 2 months after starting clopidogrel [bilirubin normal, ALT ~450 U/L, Alk P ~680 U/L], resolving in 4 weeks but recurring upon restarting). 18480537
Blombery PA, Russell PA, Daffy JR. An unusual case of recurrent fever, jaundice and right upper quadrant pain. Med J Aust 2009; 191: 396-7. (66 year old man developed jaundice 2 months after starting clopidogrel [bilirubin 5.8 mg/dL, ALT 344 U/L, Alk P 357 U/L], with improvement on stopping and recurrence within a day of restarting clopidogrel [fever and jaundice], with biopsy showing granulomas, complete resolution 2 months after permanently stopping). 19807633
Goyal RK, Srivastava D, Lessnau KD. Clopidogrel-induced hepatocellular injury and cholestatic jaundice in an elderly patient: case report and review of the literature. Pharmacotherapy 2009; 29: 608-12. (78 year old woman developed jaundice 2-3 weeks after starting clopidogrel [bilirubin 7.3 rising to 13 mg/dL, ALT 234 U/L, Alk P 1011 U/L], improving on stopping, and worsening on restarting clopidogrel and resolving upon permanent discontinuation; review of 12 published cases). 19397467
Anselmino M, Moretti C, Ravera L, Sheiban I. Clopidogrel treatment in a patient with ticlopidine-induced hepatitis following percutaneous coronary stenting. Minerva Cardioangiol 2010; 58: 277-80. (81 year old woman developed jaundice 45 days after starting ticlopidine [details not given] and recovered after stopping; one year later clopidogrel was started without recurrence of liver injury). 20440256
Kastalli S, El Aïdli S, Zaïem A, ben Abdallah H, Daghfous R. Fatal liver injury associated with clopidogrel. Fundam Clin Pharmacol 2010; 24: 433-5. (63 year old man developed jaundice 19 days after starting clopidogrel which was continued until 54 days when he was admitted with ascites and jaundice [bilirubin 4.8 mg/dL, ALT 336 U/L, Alk P 186 U/L, prothrombin index 27%], developing progressive coma and dying 2 days later). 19895648
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to clopidogrel or other antiplatelet medications). 20949552
Leighton SP, Gordon C, Shand A. Clopidogrel, Turkey and a red herring? BMJ Case Rep 2011; 2011. pii: bcr0120113776. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/22700934) (61 year old man with history of stroke and TIAs developed jaundice one month after starting clopidogrel [bilirubin 3.3 mg/dL, ALT 3636 U/L, Alk P 364 U/L] which improved after stopping clopidogrel, but was then found to be acute hepatitis E, probably acquired while traveling in Turkey).
Monteiro PH, Dos Santos Pinheiro L, Alvoeiro L, Lucas M, Victorino RM. Clopidogrel-induced liver failure. JRSM Short Rep 2011; 2: 40. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21637401) (80 year old woman with diabetes and coronary artery disease developed nausea and dyspnea 1 month after starting clopidogrel [bilirubin 1.7 mg/dL, ALT 190 U/L, GGT 166 U/L, INR rising to 1.6] who worsened for a week, but then resolved within 1 month once clopidogrel was stopped).
Pisapia R, Abdeddaim A, Mariano A, Rianda A, Vincenzi L, Taibi C, Baiocchini A, et al. Acute hepatitis associated with clopidogrel: a case report and review of the literature. Am J Ther 2015; 22: e8-e13. (53 year old woman developed fatigue, rash followed by jaundice 3 months after starting atorvastatin and 2 days after starting clopidogrel [bilirubin 5 mg/dL, ALT 1603 U/L, Alk P 408 U/L, INR 1.14], and did not improve after stopping atorvastatin [bilirubin rising to 24.5, INR 1.8], but did after stopping clopidogrel). 23846525
Zahno A, Bouitbir J, Maseneni S, Lindinger PW, Brecht K, Krähenbühl S. Hepatocellular toxicity of clopidogrel: Mechanisms and risk factors. Free Radic Biol Med 2013; 65C: 208-16. (In vitro studies of clopidogrel effects on hepatocytes suggested that low cellular glutathione and high CYP 3A4 activity may predispose to hepatotoxicity). 23770199
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23419359) (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to clopidogrel).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/24552865) (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to clopidogrel).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to clopidogrel).
Kapila A, Chhabra L, Locke AD, Patel P, Khanna A, Reddy CM, Young MF. An idiosyncratic reaction to clopidogrel. Perm J 2015; 19: 74-6. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25663208) (75 year old woman developed fever 5 days after starting clopidogrel [bilirubin 1.6 mg/dL, ALT 716 U/L, Alk P 160 U/L], which resolved rapidly upon stopping and rechallenge resulted in rise in ALT [42 to 92 U/L] and AST [49 to 120 U/L] within two days).
Keshmiri H, Behal A, Shroff S, Berkelhammer C. Clopidogrel-induced severe hepatitis: a case report and literature review. Case Reports Hepatol 2016; 2016: 8068276. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27429813) (34 year old man developed jaundice 4 months after starting clopidogrel [bilirubin 5.7 mg/dL, ALT 1393 U/L, Alk P 130 U/L, INR 1.5], worsening for a week and improving thereafter on a brief course of prednisone and ursodiol).
Etxeberria Lekuona D, Méndez López I, Mercado MR, Oteiza J, Arteaga M, Jarne V. [Cholestasic toxic hepatitis due to clopidogrel in a patient with multiple conditions]. An Sist Sanit Navar 2016; 39: 143-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27125614) (78 year old man with diabetes and renal insufficiency developed metabolic acidosis and liver test abnormalities 4 months after starting clopidogrel [bilirubin 2.1 mg/dL, ALT 106 U/L, Alk P 1441 U/L], laboratory tests improving, but not completely upon stopping).
Papagni S, Bonifati C, Dagostino F, Murgo AM. [Clopidogrel- induced hepatotoxicity in hemodialyzed patient: a case report]. G Ital Nefrol 2016; 33. pii: gin/33.1.7. Italian. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26913747) (71 year old diabetic on hemodialysis developed jaundice and ascites shortly after starting clopidogrel, which improved slowly upon stopping).
Drug interaction: Clopidogrel and PPIs. Med Lett Drugs Ther 2017; 59 (1515): 39-40. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28222065) (Concurrent use of clopidogrel and omeprazole may decrease the antiplatelet activity, but the clinical significance of the effect has not been shown).

## OTHER REFERENCE LINKS

1. Recent References on Clopidogrel: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Clopidogrel/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Clopidogrel: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clopidogrel)